# Tisotumab Vedotin

## OVERVIEW

### Introduction

Tisotumab vedotin is a human monoclonal antibody conjugate which is used in the therapy of refractory, recurrent or metastatic cervical cancer. Tisotumab vedotin has been linked to transient mild-to-moderate serum aminotransferase elevations during therapy but has not been implicated in cases of liver injury with jaundice.

### Background

Tisotumab vedotin (ti” so’ tue mab) vedotin (ve doe’ tin) is a human IgG1 kappa monoclonal antibody to tissue factor (TF), a cell surface protein that is highly expressed in various forms of cancer and is associated with poor outcomes. The monoclonal antibody is conjugated using a linker sequence to a cytotoxic molecule, vedotin monomethyl auristatin E (MMAE) that disturbs microtubule formation resulting in cell-cycle arrest and apoptosis. When tisotumab binds to TF on cancer cells, it is internalized, and vedotin is released by the action of lysosomal enzymes which cleave the short linker molecule that joins the antibody and cytotoxin. Once released, the intracellular vedotin binds to microtubules preventing their participation in cell division resulting in in apoptotic cell death of the rapidly dividing malignant cells. This monoclonal antibody conjugate has been shown to be effective in inducing remissions in adults with refractory, recurrent or metastatic cervical cancers that express TF. Tisotumab vedotin was given accelerated approval for treatment of adults with refractory recurrent or metastatic forms of cervical cancer in the United States in 2021. Tisotumab vedotin is available in powder for reconstitution in single dose vials of 40 mg under the brand name Tivdak. The typical recommended dose is 2 mg/kg (up to a maximum of 200 mg) administered by intravenous infusion every three weeks until disease progression or unacceptable toxicity. Side effects are common and may include infusion reactions, fatigue, nausea, alopecia, epistaxis, conjunctivitis, keratitis, dry eyes, hemorrhage, constipation, diarrhea, and rash. Anemia, lymphopenia, neutropenia, and increases in serum creatinine and INR can also occur. Less common, but potentially serious side effects included peripheral neuropathy, hemorrhage, pneumonitis, severe cutaneous reactions including Stevens Johnson syndrome, and embryo-fetal toxicity. Tisotumab vedotin should be administered only by physicians and health care providers with training and expertise in cancer chemotherapy and management of its potential adverse effects.

### Hepatotoxicity

In publications of the registration trials of tisotumab vedotin, serum aminotransferase elevations arose in 11% to 24% of treated patients but were above 5 times the upper limit of normal (ULN) in only 1% to 2%, and no patient developed clinically apparent liver injury attributed to therapy. The conjugated vedotin is an active metabolite of irinotecan which is a well-known cause of hepatic steatosis and liver injury, but cases are rarely clinically apparent. Since its approval and more widespread use, there have been no instances of clinically apparent liver injury attributed to tisotumab vedotin reported in the literature.

Likelihood score: E (unlikely cause of clinically significant liver injury).

### Mechanism of Injury

The cause of the serum aminotransferase elevations during tisotumab vedotin therapy is not known, but it is likely due to direct toxicity of the vedotin conjugate rather than the monoclonal antibody. It is not known whether the serum enzyme elevations are accompanied by hepatic steatosis.

### Outcome and Management

The serum aminotransferase elevations that occur during tisotumab vedotin therapy are generally transient, mild and asymptomatic and rarely require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal, if detected, should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. Elevations above 20 times the ULN or any elevation accompanied by jaundice or symptoms should lead to prompt permanent discontinuation.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Ado-Trastuzumab Emtansine, Benlantamab Mafodotin, Brentuximab Vedotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Trastuzumab Deruxtecan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tisotumab Vedotin – Tivdak®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Tisotumab%20Vedotin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tisotumab Vedotin | 1418731-10-8 (https://pubchem.ncbi.nlm.nih.gov/compound/Tisotumab-Vedotin) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2023

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/761208Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial multidiscipline review of tisotumab vedotin mentions that the most common side effects were hemorrhage, fatigue, nausea, peripheral neuropathy, alopecia, epistaxis, conjunctival and ocular toxicity including dry eyes, corneal ulcers, keratitis and perforation; ALT elevations arose in 24% of patients, but none were above 5 times ULN, there were no drug discontinuations or deaths from liver injury, and no patient developed clinically apparent liver injury with jaundice).
de Bono JS, Concin N, Hong DS, Thistlethwaite FC, Machiels JP, Arkenau HT, Plummer R, et al. Tisotumab vedotin in patients with advanced or metastatic solid tumours (InnovaTV 201): a first-in-human, multicentre, phase 1-2 trial. Lancet Oncol. 2019;20:383-393. (Among 147 patients with miscellaneous advanced or metastatic solid tumors treated with various doses tisotumab vedotin to identify the optimal dose for long term therapy [0.3 to 2.2 mg/kg iv every 3 weeks] the recommended dose was 2 mg/kg, which was associated with an overall response rate of 16% but also a high rate of adverse events including epistaxis, fatigue, nausea, alopecia, conjunctivitis, dry eyes, decreased appetite, constipation, diarrhea, peripheral neuropathy, and abdominal pain; ALT elevations arose in 10%, but were generally mild). 30745090
Joubert N, Beck A, Dumontet C, Denevault-Sabourin C. Antibody-drug conjugates: the last decade. Pharmaceuticals (Basel). 2020;13:245. (Review of the development, structure, efficacy, adverse event rates and approval of vector-based chemotherapy using selective delivery by a monoclonal antibody and cancer cell injury by a conjugated cellular toxin [payload], including nine that are FDA approved and six others in pivotal trials). 32937862
Coleman RL, Lorusso D, Gennigens C, González-Martín A, Randall L, Cibula D, Lund B, et al.; innovaTV 204/GOG-3023/ENGOT-cx6 Collaborators. Efficacy and safety of tisotumab vedotin in previously treated recurrent or metastatic cervical cancer (innovaTV 204/GOG-3023/ENGOT-cx6): a multicentre, open-label, single-arm, phase 2 study. Lancet Oncol. 2021;22:609-619. (Among 101 patients with recurrent or metastatic cervical cancer refractory to conventional therapies who were treated with tisotumab vedotin, the overall response rate was 24% and adverse events were frequent, but there was no mention of ALT elevations or hepatotoxicity). 33845034
Markham A. Tisotumab vedotin: first approval. Drugs. 2021;81:2141-2147. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of tisotumab vedotin mentions that serious adverse events included keratitis, conjunctivitis, peripheral neuropathy, hemorrhage, and pneumonitis, fatigue occurred in half of patients and serious adverse events in 43% that led to dose interruptions in 47%, reductions in 23%, discontinuations in 13% and deaths in 4%; ALT elevations arose in 24% but none were above 5 times ULN or associated with symptoms or jaundice). 34748188
Fu Z, Gao C, Wu T, Wang L, Li S, Zhang Y, Shi C. Peripheral neuropathy associated with monomethyl auristatin E-based antibody-drug conjugates. iScience. 2023;26:107778. (Rates of peripheral neuropathy are higher with antineoplastic monoclonal antibody conjugates with microtubule inhibitors such as vedotin compared to other cytotoxins, overall rates ranging from 8-66%, severe rates from <1% to 12%, caused probably by release of the monomethyl auristatin E toxin from the targeted cells to the systemic circulation or by direct uptake of the monoclonal conjugate by peripheral nerve Schwann cells). 37727735
Vergote I, Van Nieuwenhuysen E, O'Cearbhaill RE, Westermann A, Lorusso D, Ghamande S, Collins DC, et al. Tisotumab vedotin in combination with carboplatin, pembrolizumab, or bevacizumab in recurrent or metastatic cervical cancer: results from the innovaTV 205/GOG-3024/ENGOT-cx8 Study. J Clin Oncol. 2023;41(36):5536-5549. (Among 101 patients with recurrent or metastatic cervical cancer treated with tisotumab combined with either carboplatin, pembrolizumab or bevacizumab, overall response rates were 55% vs 41% vs 35%, and the carboplatin arm was best tolerated; no mention of hepatotoxicity and variability in reporting of serum enzyme elevations in the three groups). 37651655

## OTHER REFERENCE LINKS

Recent References on Tisotumab Vedotin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tisotumab+AND+Vedotin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tisotumab Vedotin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tisotumab%20Vedotin)